# Repaglinide

## OVERVIEW

### Introduction

Repaglinide is a benzoic acid derivative that stimulates insulin secretion from the pancreas and is used in the therapy of type 2 diabetes. Repaglinide has been linked to rare instances of clinically apparent acute liver injury.

### Background

Repaglinide (re pag' li nide) is an insulin secretagogue that is similar in action but different in structure from the sulfonylureas. It is a benzoid acid derivative that, like the sulfonylureas, stimulates insulin secretion by blocking ATP sensitive potassium channels in pancreatic beta-cells, causing cell membrane depolarization which results in calcium influx and insulin secretion. Repaglinide has been shown to reduce the postprandial increase in glucose in patients with type 2 diabetes and improve glycemic control. Repaglinide was approved for use in the United States in 1997. The current indications are for management of type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents. Repaglinide is available generically and under the brand name Prandin in tablets of 0.5, 1 and 2 mg. The typical initial dose in adults is 0.5 mg three times daily before meals, with a gradual increase to a maximum of 16 mg daily. Side effects of repaglinide include diarrhea, nausea, gastrointestinal upset, hypoglycemia, headache, dizziness, arthralgia and rash.

### Hepatotoxicity

In several large clinical trials, serum aminotransferase elevations during repaglinide therapy were uncommon and similar in frequency with placebo. All serum enzyme elevations that occurred were asymptomatic and resolved rapidly with stopping therapy. Since its approval and with wide scale use, there have been a small number of reports of clinically apparent liver injury attributed to repaglinide. The time to onset ranged from 2 to 8 weeks and the pattern of serum enzyme elevations was typically cholestatic or mixed. Jaundice and pruritus were prominent. Immunoallergic features and autoantibodies were not present. All published cases have been self-limited, resolving within 1 to 2 months of stopping.

Likelhood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of repaglinide induced liver injury is not known, but it is extensively metabolized by the liver via the P450 system (CYP 3A4), and liver injury may be the result of production of a toxic or immunoreactive intermediate.

### Outcome and Management

The severity of liver injury attributed to repaglinide has ranged from mild serum enzyme elevations to clinically apparent cholestatic hepatitis. Acute liver failure, vanishing bile duct syndrome and chronic liver injury have not been linked to repaglinide therapy. There is no information on results of rechallenge on cross sensitivity to hepatic damage among the various metiglinides; reexposure and use of other metiglinides after clinically apparent liver injury related to repaglinide should be done with caution.

References regarding the safety and hepatotoxicity of nateglinide and repaglinide are given with the Overview section on the Metiglinide Analogues (updated: June 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass Metiglinide Analogues: Nateglinide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Repaglinide – Generic, Prandin®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Repaglinide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Repaglinide | 135062-02-1 | C27-H36-N2-O4 | Repaglinide Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Repaglinide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Repaglinide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Repaglinide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Repaglinide)